# Vinca Alkaloids

VINBLASTINE, VINCRISTINE, VINORELBINE

## OVERVIEW

### Introduction

The vinca alkaloids include vincristine, vinblastine and vinorelbine which are important antineoplastic agents used in many chemotherapeutic regimens for a wide variety of cancers. Despite their cytotoxic activity against cancer cells, the vinca alkaloids have rarely been implicated in causing clinically apparent acute liver injury.

### Background

The vinca alkaloids are antineoplastic agents that act by binding to intracellular tubulin, the basic protein subunit of microtubules which are important in many intracellular processes including mitosis and cell division. The vinca alkaloids inhibit cell division by blocking mitosis; they also inhibit purine and RNA synthesis causing death of rapidly dividing cells. Vincristine and vinblastine were initially isolated from periwinkle (vinca rosea), extracts of which were found to have antitumor activity. Subsequently, they have been synthesized, although their structure is quite complex. Vinorelbine is a semisynthetic derivative of extracts of periwinkle. Vincristine (vin kris' teen) was approved for use in cancer chemotherapy in 1963, vinblastine (vin blas' teen) in 1965 and vinrelbine (vin or' el been) in 1994. Vincristine and vinblastine have become major components of many combination anticancer regimens, used particularly in treatment of acute leukemia, Hodgkin disease and other lymphomas, various sarcomas, Wilms tumor, neuroblastoma, and breast and lung cancer. Vinorelbine has had a more restricted use and is approved only for advance non-small cell lung cancer. The vinca alkaloids are given intravenously, typically at one or two week intervals in cycles with other agents. Importantly, the vinca alkaloids should only be given intravenously; if given intrathecally, they cause a progressive neurological syndrome, ascending paralysis and death. The vinca alkaloids are available in generic forms and under the trade names Oncovin (vincristine), Velban (vinblastine) and Navelbine (vinorelbine). Side effects are common and include nausea, vomiting, fatigue, headache, dizziness, peripheral neuropathy, hoarseness, ataxia, dysphagia, urinary retention, constipation, diarrhea, bone marrow suppression, alopecia and phlebitis at the infusion site. Uncommon but potential severe adverse events include severe neutropenia, bleeding, peripheral neuropathy, pulmonary toxicity, hypersensitivity reactions and embryo-fetal toxicity.

### Hepatotoxicity

Despite being cytotoxic for cancer cells and metabolized actively by the liver, the vinca alkaloids have only rarely been associated with significant hepatic toxicity. Because they are usually given with other anticancer agents and/or radiotherapy, which may also be hepatotoxic, the role that they play in causing liver injury is not always clear. When given on their own, the vinca alkaloids are associated with transient and asymptomatic elevations in serum aminotransferase levels in 5% to 10% of patients. However, clinically apparent liver injury attributed to the vinca alkaloids has been rare and not well defined. Both vincristine and vinblastine may increase the risk of sinusoidal obstruction syndrome, also known as venoocclusive disease of the liver, caused by radiation, dactinomycin or the alkylating agents, but not when given on their own. In these situations, the risk of sinusoidal obstruction syndrome is greater with higher doses of radiation, dactinomycin or cyclophosphamide and younger age (in children).

Likelihood score, vincristine: C (probable rare cause of clinically apparent liver injury).

Likelihood score, vinblastine: E* (unproven but suspected rare cause of clinically apparent liver injury)

Likelihood score, vinorelbine: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why the vinca alkaloids are not particularly toxic to liver cells is not known, but cell division and mitosis (the major targets of vincristine and vinblastine) are rare in the resting liver. Both agents are extensively metabolized in the liver and excreted in bile.

### Outcome and Management

Serum enzyme elevations are not uncommon during cancer chemotherapy and may occasionally be dose limiting; however, the vinca alkaloids are rarely the sole or major reason for significant or persistent enzyme elevations or clinically apparent liver injury. Patients who develop sinusoidal obstruction syndrome, but recover, can be safely treated with further courses of vincristine alone or combined with reduced doses of the alkylating agent or dactinomycin.

Drug Class: Antineoplastic Agents

## CASE REPORT

### Case 1. Fatal sinusoidal obstruction syndrome after abdominal irradiation and vincristine therapy.(1)

A 30 year old woman with poorly differentiated lymphocytic nodular lymphoma was treated with prednisone and weekly infusions of vincristine and once weekly oral streptonigrin (an antibiotic and bioreductive antineoplastic agent). Vincristine was withdrawn after 4 cycles because of neuropathy. After 6 cycles of chemotherapy, she underwent mediastinal (2000 rads) and abdominal (2225 rads) irradiation over a two month period with another cycle of vincristine (day 88). On day 111, which was 10 days after finishing radiation therapy and 33 days after the fifth and last infusion of vincristine, she developed pancytopenia, fever, abdominal pain, ascites and jaundice. Serum aminotransferase levels were markedly elevated with only modest increases in alkaline phosphatase. The fever and pancytopenia resolved with antibiotic therapy, but she developed progressive jaundice and hepatic failure and died 4 weeks later. Autopsy showed an enlarged, congested liver with sinusoidal obstruction and severe centrilobular necrosis. The autopsy showed no residual evidence of lymphoma.

#### Key Points

Medication: | Vincristine, hepatic irradiation
Pattern: | Hepatocellular (R=~100)
Severity: | 5+ (hepatic failure and death)
Latency: | 111 days after starting vincristine, 10 days after irradiation
Recovery: | None
Other medications: | Prednisone, streptonigrin

#### Laboratory Values

Days After Starting | Chemo Therapy | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
1 | Started oral prednisone and weekly doses of vincristine and streptonigrin
11 | V & S | 9 | 105 | 0.8
17 | V & S | 10 | 100
24 | V & S | 11 | 105
31 | S | 13 | 90
38 | S | 11 | 90
53 | Rad | 15 | 135
88 | Rad & V | 25 | 140
111 | Admission | 4000 | 255 | 5.8 | Jaundice, ascites, fever
113 | Day 2 | 1550 | 230 | 6.0
117 | Day 6 | 185 | 265 | 10.0
122 | Day 11 | 88 | 405 | 20.0
131 | Day 20 | 62 | 340 | 20.5
141 | Day 30 | Died of hepatic failure
Normal Values | | <30 | <275 | <1.2

* Abbreviations: Rad=radiation therapy, S=oral streptonigrin, V=vincristine infusion.

#### Comment

The clinical presentation with weight gain, abdominal pain, ascites and jaundice is typical of sinusoidal obstruction syndrome. Hepatic irradiation, dactinomycin, and the alkylating agents (dacarbazine, cyclophosphamide, myleran and busulfan) are most frequently associated with this form of liver injury. The injury is probably due to direct toxicity to sinusoidal lining cells with their subsequent necrosis and extrusion into the sinusoidal spaces, which causes obstruction, hemorrhage and local ischemia to hepatocytes. Signs of portal hypertension appear early, followed (in severe cases) by jaundice and hepatic failure. The dose of radiation used in this patient (<3000 rads) was not considered adequate to cause sinusoidal obstruction syndrome on its own, which suggested that vincristine might have increased the risk of this complication.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vinblastine – Generic, Velban®

Vincristine – Generic, Oncovin®

Vinorelbine – Generic, Navelbine®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=vinblastine) (Vinblastine)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=vincristine) (Vincristine)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=vinorelbine) (Vinorelbine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Vinblastine | 865-21-4 | C46-H58-N4-O9
Vincristine | 57-22-7 | C46-H56-N4-O10
Vinorelbine | 71486-22-1 | C45-H54-N4-O8

## CITED REFERENCE

1 Hansen MM, Ranek L, Walbom S, Nissen NI. (1982). Fatal hepatitis following irradiation and vincristine. Acta Med Scand.

## ANNOTATED BIBLIOGRAPHY

References updated: 12 September 2020

Abbreviations: ABVD, doxorubicin, bleomycin, vinblastine and dacarbazine; BEACOPP, bleomycin, etoposide, doxorubicin, cyclophosphamide, vincristine, procarbazine and prednisone; CHOP, chemotherapy regimen of cyclophosphamide, doxorubicin, vincristine and prednisone; G-CHOP, obinutuzumab with CHOP; R-CHOP, rituximab with CHOP; SOS, sinusoidal obstruction syndrome.

Zimmerman HJ. The vinca alkaloids. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 692-4. (Expert review of hepatotoxicity published in 1999 mentions that vincristine and vinblastine appear to cause little hepatic injury in humans or experimental animals).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of published in 2007; mentions that vincristine may increase the risk of sinusoidal obstruction syndrome caused by dactinomycin).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-730. (Textbook of pharmacology and therapeutics).
Costa G, Hreshchyshyn MM, Holland JF. (1962). Initial clinical studies with vincristine. Cancer Chemother Rep. (Preliminary studies of vincristine against various cancers; dose limiting side effects included peripheral neuropathy and bone marrow suppression; 5 of 12 patients had patchy hepatic necrosis on autopsy despite having no abnormalities of liver tests before death).
Bohannon RA, Miller DG, Diamond HD. (1963). Vincristine in the treatment of lymphomas and leukemias. Cancer Res. (Review of mechanism of action, clinical efficacy and toxicity of vincristine; AST elevations occurred in a small proportion of patients, but were not dose-limiting).
Raine J, Bowman A, Wallendszus K, Pritchard J. (1991). Hepatopathy-thrombocytopenia syndrome–a complication of dactinomycin therapy for Wilms' tumor: a report from the United Kingdom Childrens Cancer Study Group. J Clin Oncol. (Among 355 children with Wilms tumor who received the combination of dactinomycin and vincristine, 5 developed “hepatopathy-thrombocytopenia syndrome” [bilirubin 1.3-6.1 mg/dL, ALT 335-5723 U/L], but none of 146 given vincristine alone developed this syndrome).
Hansen MM, Ranek L, Walbom S, Nissen NI. (1982). Fatal hepatitis following irradiation and vincristine. Acta Med Scand. (30 year old woman with lymphoma developed SOS after liver irradiation and chemotherapy with vincristine [bilirubin 6.0 rising to 21.0 mg/dL, AST 4000 U/L, Alk P 250 U/L], with progressive multiorgan failure and death 4 weeks later: Case 1).
el Saghir NS, Hawkins KA. (1984). Hepatotoxicity following vincristine therapy. Cancer. (49 year old woman with lung cancer treated with VP-16, cyclophosphamide and vincristine developed ALT elevations [2 to 6 times ULN] a week after chemotherapy with normal bilirubin levels and liver biopsy; ALT elevations recurred when vincristine was given alone).
Green DM, Finklestein JZ, Norkool P, D'Angio GJ. (1988). Severe hepatic toxicity after treatment with single-dose dactinomycin and vincristine. A report of the National Wilms' Tumor Study. Cancer. (5 children, ages 1 to 8 years, developed severe hepatic injury [SOS] 2-9 days after the 2nd or 3rd course of dactinomycin and vincristine, and 1 died; no recurrence when vincristine was restarted alone or with reduced and split doses of dactinomycin).
Green DM, Norkool P, Breslow NE, Finklestein JZ, D'Angio GJ. (1990). Severe hepatic toxicity after treatment with vincristine and dactinomycin using single-dose or divided-dose schedules: a report from the National Wilms' Tumor Study. J Clin Oncol. (Retrospective analysis of 154 children with Wilms tumor treated with dactinomycin and vincristine found higher rate of hepatotoxicity with higher single dose dactinomycin [14%] than with lower [4%] or split doses [3%]; clinical presentation with ascites, elevated AST [529 to 8208 U/L] and 50% with jaundice).
Zhou XJ, Rahmani R. (1992). Preclinical and clinical pharmacology of vinca alkaloids. Drugs. (Review of structure, mechanism of action, pharmacology, clinical efficacy and toxicities of vinca alkaloids; hepatotoxicity not discussed).
Bisogno G, de Kraker J, Weirich A, Masiero L, Ludwig R, Tournade MF, Carli M. (1997). Veno-occlusive disease of the liver in children treated for Wilms tumor. Med Pediatr Oncol. (Among 511 children with Wilms tumor treated with dactinomycin and vincristine with or without other agents or irradiation, 64 [12%] had hepatotoxicity including 41 [8%] with SOS [all with hepatomegaly, 83% ascites, 28% jaundice, 6% fatal]; rates higher in children <1 years of age and those who received irradiation [12% vs 7%]).
Ortega JA, Donaldson SS, Ivy SP, Pappo A, Maurer HM. (1997). Venoocclusive disease of the liver after chemotherapy with vincristine, actinomycin D, and cyclophosphamide for the treatment of rhabdomyosarcoma. A report of the Intergroup Rhabdomyosarcoma Study Group. Childrens Cancer Group, the Pediatric Oncology Group, and the Pediatric Intergroup Statistical Center. Cancer. (Among 821 children [ages 2 to 15 years] with rhabdomyosarcoma treated with vincristine, dactinomycin and cyclophosphamide, 10 [1.2%] developed SOS and 1 died; single major risk factor was higher doses of cyclophosphamide).
Nishihori Y, Yamauchi N, Kuribayashi K, Sato Y, Morii K, Hirayama Y, Sakamaki S, et al. (2000). Rinsho Ketsueki. (Abstract only: 11 year old boy with leukemia and chronic hepatitis C developed severe hemolysis and died of hepatic failure while being treated with vincristine).
van der Hul RL, Seynaeve C, van Geel BN, Verweij J. (2003). Low dose methotrexate and vinblastine, given weekly to patients with desmoid tumours, is associated with major toxicity. Sarcoma. (Among 10 patients with desmoid tumors given methotrexate [50 mg/week] and vinblastine [10 mg/week], severe side effects were common and 2 developed transient ALT elevations [3 to 10 times ULN] without jaundice).
Arndt C, Hawkins D, Anderson JR, Breitfeld P, Womer R, Meyer W. (2004). Age is a risk factor for chemotherapy-induced hepatopathy with vincristine, dactinomycin, and cyclophosphamide. J Clin Oncol. (Among 339 children with rhabdomyosarcoma treated with vincristine, dactinomycin and cyclophosphamide, 18 [6%] developed hepatotoxicity and 3 died [1%]; risk of liver injury was greater in children <3 years of age [15% vs 4%]).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 2 to antineoplastic agents [melphalan and gemtuzumab], but none to vincristine or vinblastine).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contains 9036 hepatic adverse drug reactions in children; vincristine accounted for 46 instances, ranking 26th).
Langholz B, Skolnik JM, Barrett JS, Renbarger J, Seibel NL, Zajicek A. (2011). Arndt CAs. Dactinomycin and vincristine toxicity in the treatment of childhood cancer: a retrospective study from the Children's Oncology Group. Pediatr Blood Cancer. (Retrospective review of six pediatric cancer clinical trials, comprising 4567 patients; the review found an overall risk for hepatotoxicity due to dactinomycin to be between 10-15%, depending upon age and type of tumor being treated; patients <1 year of age were at greater hepatotoxicity risk; vincristine was not associated with liver injury in this review).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to a vinca alkaloid).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to a vinca alkaloid).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 363 [36%] were attributed to antibiotics, only one of which was attributed to a vinca alkaloid, vincristine in a 42 year old woman with HIV infection and lymphoma treated with combination chemotherapy and developing jaundice within a few weeks, bilirubin rising to 17.9, ALT 82 U/L, Alk P 265 U/L; resolving and later tolerating the other drugs in the combination).
Wang J, Zheng R, Wang Z, Yang Y, Wang M, Zou W. (2017). Efficacy and safety of vinorelbine plus cisplatin vs. gemcitabine plus cisplatin for treatment of metastatic triple-negative breast cancer after failure with anthracyclines and taxanes. Med Sci Monit. (Among 48 patients with refractory metastatic breast cancer treated with cisplatin combined with either vinorelbine or gemcitabine, objective response rates were similar [46%], as was time to progression and adverse events; mild [grade 1 or 2] “hepatic dysfunction” arose in 27% of both groups and did not require dose modification or progress to clinically apparent liver injury).
Eslami A, Mathur AD, Jha KK, Wang H. (2018). Acute liver failure secondary to ABVD use. BMJ Case Rep. (79 year old woman with Hodgkin disease was found unconscious 3 hours after completing a first cycle of ABVD [doxorubicin, bleomycin, vinblastine and dacarbazine], with liver injury arising over the next 24 hours [bilirubin 2.6 mg/dL on day 2, ALT 980 U/L, Alk P 126, lactate 5.3 mmol/L], with rapid recovery).
Tanoshima R, Khan A, Biala AK, Trueman JN, Drögemöller BI, Wright GEB, Hasbullah JS, et al., Canadian Pharmacogenomics Network for Drug Safety Consortium. (2019). Analyses of adverse drug reactions-nationwide active surveillance network: Canadian Pharmacogenomics Network for Drug Safety Database. J Clin Pharmacol. (Among 10,475 adverse drug reaction reports made to a Canadian pharmacovigilance registry between 2005 and 2017 from 26 medical centers, 73% were pediatric and the most commonly implicated drugs were antineoplastic agents, including methotrexate, vincristine, doxorubicin, cisplatin, L-asparaginase, cyclophosphamide, dexamethasone, cytarabine and etoposide, hepatotoxicity being the 10th most common type of reaction [194 cases]).
Peng S, Yang K, Xu Z, Chen S, Ji Y. (2019). Vincristine and sirolimus in the treatment of kaposiform haemangioendothelioma. J Paediatr Child Health. (Metaanalysis of trials of vincristine and sirolimus for Kaposiform hemangioendothelioma identified 5 studies in 75 patients of vincristine, with adverse event reports from 16 subjects, the most common events being neuropathy [38%], abdominal pain [19%], anorexia [6%] and transient ALT elevations [12%]; no mention of clinically apparent liver injury).
Younes A, Sehn LH, Johnson P, Zinzani PL, Hong X, Zhu J, Patti C, et al., PHOENIX investigators. (2019). Randomized phase III trial of ibrutinib and rituximab plus cyclophosphamide, doxorubicin, vincristine, and prednisone in non-germinal center B-cell diffuse large B-cell lymphoma. J Clin Oncol. (Among 838 patients with large B cell lymphoma treated with R-CHOP with or without ibrutinib, overall survival was not improved by ibrutinib, but serious side effects were greater [53% vs 34%]; no mention of ALT elevations or hepatotoxicity).
Poeschel V, Held G, Ziepert M, Witzens-Harig M, Holte H, Thurner L, Borchmann P, et al., FLYER Trial Investigators. (2019). German Lymphoma Alliance. Four versus six cycles of CHOP chemotherapy in combination with six applications of rituximab in patients with aggressive B-cell lymphoma with favourable prognosis (FLYER): a randomised, phase 3, non-inferiority trial. Lancet. (Among 592 patients with B cell non-Hodgkin lymphoma treated with 6 cycles of R-CHOP vs 4 cycles with 2 further cycles of rituximab alone, progression free survival was similar in the two groups while adverse events were more with the 6 cycles; no mention of ALT elevations or hepatotoxicity).
Brühwiler LD, Schwappach DL. (2020). Safe vincristine use in Switzerland: still a long way to go?. J Oncol Pharm Pract. (The medical error of administration of vincristine intrathecally instead of intravenously leads to progressive decerebration and death within a few days, and international recommendations to prevent this error have not been rigorously adopted as shown by surveys of pharmaceutical services in Switzerland).
Sehn LH, Martelli M, Trněný M, Liu W, Bolen CR, Knapp A, Sahin D, et al. (2020). A randomized, open-label, Phase III study of obinutuzumab or rituximab plus CHOP in patients with previously untreated diffuse large B-Cell lymphoma: final analysis of GOYA. J Hematol Oncol. (Among 1414 patients with large B cell lymphoma treated with CHOP and either rituximab [R-CHOP] or obinutuzumab [G-CHOP] [both monoclonal antibodies to CD20], progression-free survival rates were similar [64% and 63%] as were total adverse events, but serious events were more frequent with G-CHOP [44% vs 38%]; no mention of ALT elevations or hepatotoxicity).
Dalal M, Gupta J, Price K, Zomas A, Miao H, Ashaye A. (2020). Efficacy and safety of front-line treatments for advanced Hodgkin lymphoma: a systematic literature review. Expert Rev Hematol. (Systematic review of first line therapies of advance Hodgkin disease focused on ABVD [doxorubicin, bleomycin, vinblastine and dacarbazine] and BEACOPP [bleomycin, etoposide, doxorubicin, cyclophosphamide, vincristine, procarbazine and prednisone], discussing side effects of pulmonary toxicity, secondary malignancies, neutropenia and peripheral neuropathy but not hepatotoxicity or ALT elevations).

## OTHER REFERENCE LINKS

1 Recent References on Vinca Alkaloids: from PubMed.gov (http://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=vinca+alkaloids+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Vinca Alkaloids: from ClinicalTrials.gov (http://clinicaltrials.gov/ct2/results?term=vinca+alkaloids)